# Dolutegravir

## OVERVIEW

### Introduction

Dolutegravir is a human immunodeficiency virus (HIV) integrase inhibitor, the third in this class of agents that target the viral integrase. Dolutegravir is used only in combination with other antiretroviral agents in the treatment of HIV infection, and it has had limited use. Dolutegravir is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of acute, clinically apparent liver injury.

### Background

Dolutegravir (doe" loo teg' ra vir) is relatively new antiretroviral drug that targets the HIV integrase, one of the three viral enzymes involved in replication. Dolutegravir blocks the binding site of the HIV integrase and prevents the strand transfer activity and integration of the provirus into the host genome. Dolutegravir has both in vitro and in vivo activity against HIV, and several randomized controlled trials have shown that it can cause significant declines in HIV RNA levels and rises in peripheral CD4 T cell counts. Dolutegravir was approved for use in HIV infection in the United States in 2013 and is currently used in an increasing proportion of antiretroviral regimens. Dolutegravir is available as 50 mg tablets under the brand name Tivicay. The recommended dose regimen is 50 mg twice daily in combination with other classes of antiretroviral agents. A single tablet, fixed dose regimen of dolutegravir [50 mg], abacavir [600 mg] and lamivudine [300 mg] is also available under the name Triumeq, the recommended dose being one tablet daily. While generally well tolerated, dolutegravir therapy may be accompanied by diarrhea, headache, nausea and fever.

### Hepatotoxicity

In large clinical trials, therapy with dolutegravir was associated with alanine aminotransferase (ALT) elevations of greater than 3 times the upper limit of normal (ULN) in 2% to 5% of patients, but these rates were similar to those in comparator groups receiving matched background optimized antiretroviral therapy without dolutegravir. These elevations were not associated with clinical symptoms and generally did not require dose modification. A few instances of acute liver injury with jaundice were described in the registration trials for dolutegravir which occurred in association with hypersensitivity reactions and resolved with drug discontinuation. The clinical features of these cases were not provided and their association with dolutegravir as opposed to the concurrent antiretroviral agents was not fully established. Since its approval and more wide spread use, however, several case reports of acute hepatitis attributable to dolutegravir have appeared. The latency to onset varried from 1 to 8 months and the pattern of serum enzyme elevations was hepatocellular. Immunoallergic and autoimmune features were not present. At least one published case resulted in acute liver failure and need for liver transplanation. The product label for dolutegravir mentions hepatitis and hepatic failure as potential adverse reactions and states that patients with hepatitis B or C coinfection are susceptible to worsening or flares of hepatitis with initiation of dolutegravir therapy, perhaps as a consequence of immune reconstitution syndrome. Monitoring of liver tests is recommended in patients starting regimens that include dolutegravir.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which dolutegravir might cause liver injury is not known. Dolutegravir is metabolized by the liver, largely by glucuronidation with subsequent urinary clearance. Dolutegravir has little or no effect on microsomal cytochrome P450 enzymes. Reconstitution of immune reactivity by antiretroviral therapy in patients with an underlying chronic hepatitis B or C can be associated with a transient flare of hepatitis. This effect occurs with many potent antiretroviral regimens and is not specific to dolutegravir or the integrase inhibitors.

### Outcome and Management

Dolutegravir is associated with a low rate of serum enzyme elevations during therapy and monitoring of liver tests is recommended. Cases of acute hepatitis including fatal instances have been reported. Elevations of serum aminotransferase levels above 5 times the ULN should lead to dose interruptions and permanent discontinuation if they persist or are associated with clinical symptoms or jaundice. Switching to other antiretroviral agents is appropriate iand there does not appear to be cross sensitivity to hepatic injury among the various HIV integrase inhibitors. Dolutegravir has not been linked to cases of chronic cholestasis or vanishing bile duct syndrome.

Drug Class: Antiviral Agents

Other Drugs in the Subclass, Integrase Strand Transfer Inhibitors: Bictegravir, Cabotegravir, Elvitegravir, Raltegravir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dolutegravir – Tivicay®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dolutegravir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Dolutegravir | 1051375-16-6 | C20-H19-F2-N3-O5
Elvitegravir | 697761-98-1 | C23-H23-Cl-F-N-O5
Raltegravir | 518048-05-0 | C20-H21-F-N6-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 10 January 2018

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including drugs for HIV infection, although the integrase inhibitors are not discussed).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
https://hivinfo.nih.gov/hiv-source/medical-practice-guidelines/hiv-treatment-guidelines (Regularly updated clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Cocohoba J, Dong BJ. (2008). Raltegravir: the first HIV integrase inhibitor. Clin Ther. (Review of the mechanism of action, pharmacokinetics, and phase I-III studies of raltegravir; in combined phase III studies, ALT elevations above 5 times ULN occurred in 4.3% of 462 raltegravir treated vs 3.4% of 237 placebo treated patients who were receiving optimized background therapy; no hepatic serious adverse events were reported).
Fleischbein E, O'Brien J, Martelino R, Fenstersheib M. (2008). Elevated alkaline phosphatase with raltegravir in a treatment experienced HIV patient. AIDS. (45 year old man with AIDS developed elevated Alk P [85 rising to 1053 U/L], which resolved upon stopping and recurred on rechallenge with raltegravir; serum bilirubin, ALT and GGT levels were normal, but authors suspected liver as the source anyway).
(2012). A 4-drug combination (Stribild) for HIV. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of the single table regimen of Stribild [elvitegravir, tenofovir, emtricitabine and cobicistat], shortly after its approval in the US; does not mention ALT elevations or hepatotoxicity).
Surgers L, Lacombe K. (2013). Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol. (Review of evidence of liver injury in large clinical trials of newer antiretroviral agents including dolutegravir concluded that "the overall hepatic tolerance is far better with the novel drugs in this review than with former ARV regimens"; ALT elevations occurred with equal frequency in dolutegravir and comparator arms, and one patient on raltegravir developed DRESS syndrome).
Eron JJ, Clotet B, Durant J, Katlama C, Kumar P, Lazzarin A, Poizot-Martin I, et al., VIKING Study Group. (2013). Safety and efficacy of dolutegravir in treatment-experienced subjects with raltegravir-resistant HIV type 1 infection: 24-week results of the VIKING Study. J Infect Dis. (Among 52 HIV infected persons with raltegravir resistance who were switched to dolutegravir [50 mg once or twice daily], virological responses at 11 days were more frequent with the twice daily dosing, and there were no liver related severe adverse events and no mention of ALT levels).
Raffi F, Rachlis A, Stellbrink HJ, Hardy WD, Torti C, Orkin C, Bloch M, et al., SPRING-2 Study Group. (2013). Once-daily dolutegravir versus raltegravir in antiretroviral-naive adults with HIV-1 infection: 48 week results from the randomised, double-blind, non-inferiority SPRING-2 study. Lancet. (Among 822 treatment naïve patients with HIV infection treated with dolutegravir vs raltegravir combined with tenofovir/emtricitabine or abacavir/lamivudine, virological response rates at 48 weeks were similar [88% vs 85%] as were adverse event rates; ALT elevations above 3 times ULN occurred in 13 [3%] vs 17 [4%] patients and above 10 times ULN in 5 [1%] vs 2 [<1%], one patient in each group having “possible” drug induced liver injury, both with signs of hypersensitivity).
Stellbrink HJ, Reynes J, Lazzarin A, Voronin E, Pulido F, Felizarta F, Almond S, et al. (2013). SPRING-1 Team. Dolutegravir in antiretroviral-naive adults with HIV-1: 96-week results from a randomized dose-ranging study. AIDS. (Among 205 treatment naïve adults with HIV infection treated with one of 3 doses of dolutegravir or efavirenz once daily combined with two reverse transcriptase inhibitors, virological response rates were 78-88% with dolutegravir and 72% with efavirenz, and there were no treatment related serious adverse events; 2 patients developed ALT levels above 5 times ULN, but both were found to have acute hepatitis C).
Cahn P, Pozniak AL, Mingrone H, Shuldyakov A, Brites C, Andrade-Villanueva JF, Richmond G, et al. (2013). extended SAILING Study Team. Dolutegravir versus raltegravir in antiretroviral-experienced, integrase-inhibitor-naive adults with HIV: week 48 results from the randomised, double-blind, non-inferiority SAILING study. Lancet. (Among 715 patients with HIV infection treated with either dolutegravir or raltegravir combined with background antiretroviral therapy, adverse events were similar between the two groups and 3% vs 2% developed ALT elevations above 5 times ULN; no mention of clinically apparent liver injury).
Raffi F, Jaeger H, Quiros-Roldan E, Albrecht H, Belonosova E, Gatell JM, Baril JG, et al. (2013). extended SPRING-2 Study Group. Once-daily dolutegravir versus twice-daily raltegravir in antiretroviral-naïve adults with HIV-1 infection (SPRING-2 study): 96 week results from a randomised, double-blind, non-inferiority trial. Lancet Infect Dis. (Among 822 patients with previously untreated HIV infection given dolutegravir vs raltegravir in combination with other agents [Raffi Lancet 2013], 96 week virological response rates were 81% vs 76% and no new treated related, serious adverse events arose during the second 48 weeks of the trial; ALT elevations above 3 times ULN occurred in a total of 21 [5%] vs 19 [5%] subjects).
Walmsley SL, Antela A, Clumeck N, Duiculescu D, Eberhard A, Gutiérrez F, Hocqueloux L, et al. (2013). SINGLE Investigators. Dolutegravir plus abacavir-lamivudine for the treatment of HIV-1 infection. N Engl J Med. (Among 833 treatment naïve adults with HIV infection treated with dolutegravir with abacavir/lamivudine or efavirenz with tenofovir/emtricitabine, virological response rates at 48 weeks were higher with dolutegravir [88% vs 81%] and adverse events were less common; ALT levels above 2.5 times ULN occurred in 2% vs 5% of subjects and no patient developed clinically apparent liver injury with jaundice).
Curtis L, Nichols G, Stainsby C, Lim J, Aylott A, Wynne B, Clark A, et al. (2014). Dolutegravir: clinical and laboratory safety in integrase inhibitor-naive patients. HIV Clin Trials. (Summary of laboratory abnormalities in the registration trials of dolutegravir in adults with HIV infection found ALT elevations above 2.5 times ULN in 16% to 22% of patients with hepatitis B or C coinfection, but in only 3% with HIV infection alone; serious hypersensitivity reactions occurred only in patients who also received abacavir and no instances of severe cutaneous reactions such as Stevens Johnson syndrome occurred in dolutegravir treated subjects).
Molina JM, Clotet B, van Lunzen J, Lazzarin A, Cavassini M, Henry K, Kulagin V, et al. (2015). FLAMINGO study team. Once-daily dolutegravir versus darunavir plus ritonavir for treatment-naive adults with HIV-1 infection (FLAMINGO): 96 week results from a randomised, open-label, phase 3b study. Lancet HIV. (Among 484 treatment naïve adults with HIV infection treated with dolutegravir or darunavir/ritonavir combined with two reverse transcriptase inhibitors, virological response rates at 96 weeks were 80% vs 68%; ALT levels above 3 times ULN occurred in 5% vs 3% of patients, but no patient developed clinically apparent liver injury with jaundice and all serious liver test abnormalities were considered to have other causes).
Dolutegravir (Tivicay) for HIV. (2013). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of dolutegravir shortly after its approval for use in HIV infection in the US, mentions that it is generally well tolerated, causes hypersensitivity reactions in <1% of persons and has been associated with ALT elevations in patients with hepatitis B or C coinfection).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] cases were attributed to antiretroviral agents, but none to the integrase inhibitors - dolutegravir, elvitegravir or raltegravir).
(2015). Triumeq--a 3-drug combination for HIV. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of the fixed dose, single tablet regimen of dolutegravir, abacavir and lamivudine [Triumeq] shortly after its approval for use in HIV infection in the US, mentions that common side effects are insomnia, headache and fatigue and rare severe reactions include hypersensitivity responses with abacavir, lactic acidosis with lamivudine and abacavir and ALT elevations in patients with hepatitis B and C with dolutegravir).
Elvitegravir (Vitekta) for HIV. (2016). Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of elvitegravir shortly after its approval for separate use in HIV infection in the US, mentions that the most common side effects are diarrhea, nausea and headache; no mention of ALT elevations or hepatotoxicity).
Wang B, Abbott L, Childs K, Taylor C, Agarwal K, Cormack I, Miquel R, Suddle A. (2018). Dolutegravir-induced liver injury leading to sub-acute liver failure requiring transplantation: a case report and review of literature. Int J STD AIDS. (28 year old African woman with HIV infection developed persistent ALT elevations a month after switching from raltegravir/ tenofovir/emtricitabine to dolutegravir/abacavir/lamivudine [ALT 300 U/L], which worsened despite switching back [bilirubin 7.3 mg/dL, ALT 1636 U/L, Alk P 131 U/L, INR 2.14], ultimately requiring liver transplantation for acute liver failure).
Christensen ES, Jain R, Roxby AC. (2017). Abacavir/dolutegravir/lamivudine (Triumeq)-induced liver toxicity in a human immunodeficiency virus-infected patient. Open Forum Infect Dis. (47 year old man with HIV developed ALT elevations 8 months after starting dolutegravir/abacavir/lamivudine [bilirubin 0.8 mg/dL, ALT 343 U/L], which worsened with continuing [bilirubin 2.1 mg/dL, ALT 1004 U/L], improving on stopping and switching to elvitegravir/tenofovir/emtricitabine).

## OTHER REFERENCE LINKS

1 Recent References on Dolutegravir: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dolutegravir/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Dolutegravir: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=Dolutegravir)